# Cholic Acid

## OVERVIEW

### Introduction

Cholic acid is a naturally occurring bile acid that is used to treat patients with genetic deficiencies in the synthesis of bile acids. When given in high doses, cholic acid replacement therapy has been linked to minor elevations in serum aminotransferase levels, but it has not been linked to instances of clinically apparent acute liver injury with jaundice.

### Background

Cholic (koe' lik) acid is a naturally occurring, primary bile acid that represents a major component of the total bile acid pool in humans. Cholic acid is synthesized from cholesterol in the liver and is conjugated to either glycine (glycocholic acid) or taurine (taurocholic acid) before secretion in the bile. Bile acids act in bile to solubilize cholesterol (which is totally insoluble in water) with phospholipids in mixed micelles. Once secreted into the intestine, bile acids help to emulsify fats and aid in their digestion. Cholic acid is also a potent signaling molecule and acts as a weak FXR agonist resulting in a decrease in bile acid synthesis and parallel increase in cholesterol. For these reasons, cholic acid is not effective in gallstone dissolution. Cholic acid is used therapeutically to treat patients with bile acid synthetic defects due to single enzyme deficiencies. Defects in several of the enzymes involved in bile acid synthesis can result in the production of abnormal and insufficient levels of bile acids with resultant fat malabsorption and progressive cholestatic liver disease. Cholic acid administration reverses most of these abnormalities. Cholic acid was given orphan drug approval for use in the United States for treatment of children and adults with bile acid synthetic defects and Zellweger’s syndrome (a peroxisomal disorder characterized by progressive liver disease and malabsorption) in 2015. A glycine conjugate of cholic acid (glycocholic acid) is currently being evaluated for treatment of bile acid conjugation defects. Cholic acid is available as capsules of 50 and 250 mg under the brand name Cholbam. The typical dose is 10 to 15 mg/kg once daily. Side effects are largely dose related and include diarrhea, indigestion, nausea, abdominal discomfort, fatigue, and skin rash.

### Hepatotoxicity

In small, open label trials, cholic acid was found to improve fat soluble vitamin absorption and to ameliorate many of the clinical features of the bile acid synthetic defects including improvement in serum aminotransferase levels, decrease in bilirubin and jaundice and improvement in general health and growth. In some instances, higher doses of cholic acid were associated with elevations in serum aminotransferase levels. These abnormalities, however, were mild, transient and rapidly reversed with lowering the daily dose. There have been no reports of clinically apparent liver injury with jaundice attributed to cholic acid therapy given in standard doses.

Likelihood score: D[HD] (possible cause of liver injury but only when given in high doses).

### Mechanism of Liver Injury

The mechanism by which high doses of cholic acid might cause liver injury is unclear. An increase in cholic acid levels in hepatocytes may be mildly hepatotoxic.

Other bile acids used in digestive diseases include chenodeoxycholic acid (chenodiol), obeticholic acid and ursodeoxycholic acid (ursodiol).

Drug Class: Gastrointestinal Agents, Bile Acids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cholic Acid – Cholbam®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cholic+Acid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cholic Acid | 81-25-4 | C24-H40-O5 | Cholic Acid Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 07 November 2016

Zimmerman HJ. Bile acid derivatives. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 before the availability of cholic acid).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-50. (Textbook of pharmacology and therapeutics).
Daugherty CC, Setchell KD, Heubi JE, Balistreri WF. Resolution of liver biopsy alterations in three siblings with bile acid treatment of an inborn error of bile acid metabolism (delta 4-3-oxosteroid 5 beta-reductase deficiency). Hepatology 1993; 18: 1096-101. (Among 3 siblings with bile acid synthetic defects and severe liver disease, treatment with cholic acid and ursodiol was followed by resolution of jaundice and improvements in ALT, Alk P and liver histology). 8225213
Bove KE, Heubi JE, Balistreri WF, Setchell KD. Bile acid synthetic defects and liver disease: a comprehensive review. Pediatr Dev Pathol 2004; 7: 315-34. (Extensive review of the inherited forms of defective bile acid synthesis which are often accompanied by progressive cholestatic liver injury, some of which respond to treatment with oral bile acids, including 3β-OH steroid dehydrogenase, 5β-reductase, and mitochondrial C-27 hydroxylase deficiencies as well as several peroxisomal defects [Zellweger syndrome]). 15383928
Woollett LA, Buckley DD, Yao L, Jones PJ, Granholm NA, Tolley EA, Tso P, Heubi JE. Cholic acid supplementation enhances cholesterol absorption in humans. Gastroenterology 2004; 126: 724-31. (In a crossover design study in healthy volunteers, administration of cholic acid [15 mg/kg daily] resulted in an increase in cholesterol absorption). 14988826
Chen J, Raymond K. Nuclear receptors, bile-acid detoxification, and cholestasis. Lancet 2006; 367(9509): 454-6. (Commentary on the nuclear receptor FXR, which acts as a bile acid receptor and mediates reduction in bile acid synthesis and increase in uptake of bile acids from the circulation as well as secretion of bile acids from hepatocytes). 16473109
Wang Y, Jones PJ, Woollett LA, Buckley DD, Yao L, Granholm NA, Tolley EA, Heubi JE. Effects of chenodeoxycholic acid and deoxycholic acid on cholesterol absorption and metabolism in humans. Transl Res 2006; 148: 37-45. (In two cross over studies in adults, oral chenodiol had no effect of plasma lipid concentrations while it increased biliary chenodiol, but also increased biliary cholesterol concentrations). 16887497
Heubi JE, Setchell KD, Bove KE. Inborn errors of bile acid metabolism. Semin Liver Dis 2007; 27: 282-94. (Review of the rare inherited conditions marked by abnormal bile acid synthesis or metabolism, the diagnosis of which generally requires mass spectrometry techniques, and many of which are treatable using oral bile acids such as cholic acid, chenodiol, ursodiol and glycocholic acid). 17682975
Chiang JY. Bile acids: regulation of synthesis. J Lipid Res 2009; 50: 1955-66. (Review of the pathways of cholic and chenodeoxycholic acid synthesis and their regulation via FXR, FGF19, FGFR4 and CYP7A1). 19346330
Gonzales E, Gerhardt MF, Fabre M, Setchell KD, Davit-Spraul A, Vincent I, Heubi JE, et al. Oral cholic acid for hereditary defects of primary bile acid synthesis: a safe and effective long-term therapy. Gastroenterology 2009; 137: 1310-1320. (Among 15 patients with bile acid synthesis defects treated with oral bile acids [ursodiol and cholic acid initially, and eventually cholic acid alone for all except one patient: 3-9 mg/kg daily] for 5-15 years, all had lasting clinical improvements shown by repeat liver biopsies in 14; overdose of cholic acid was marked by diarrhea, pruritus and increases in GGT and ALT that responded to dose modification). 19622360
Heubi JE, Setchell KD, Jha P, Buckley D, Zhang W, Rosenthal P, Potter C, et al. Treatment of bile acid amidation defects with glycocholic acid. Hepatology 2015; 61: 268-74. (Treatment of 5 patients with bile acid amidation defects with glycine conjugated cholic acid [glycocholic acid; 15 mg/kg daily] resulted in improved absorption of fat soluble vitamins and growth improvement in all 3 prepubertal children with delayed growth). 25163551
In brief: Cholic acid (Cholbam) for bile acid synthesis disorders. Med Lett Drugs Ther 2016; 58 (1493): 56. (Short review of the efficacy, safety and costs of cholic acid, shortly after its approval as an orphan drug in the therapy of bile acid synthesis disorders, mentions that its most common adverse event is diarrhea). 27101212

## OTHER REFERENCE LINKS

1. Recent References on Cholic Acid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cholic+Acid/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cholic Acid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cholic+Acid)